# Varenicline

## OVERVIEW

### Introduction

Varenicline is a partial agonist of the nicotinic acetylcholine receptor and is used to help in smoking cessation. Varenicline has been associated with a low rate of serum enzyme elevations during therapy and, since approval and its widescale use, with rare instances of clinically apparent mild liver injury.

### Background

Varenicline (var en' i kleen) is a partial agonist of the α4 β2 nicotinic acetylcholine receptor and appears to act by blocking the binding of nicotine to this receptor while providing partial agonist effect thus relieving nicotine craving. Use of varenicline in a program to stop smoking has been shown to increase the rate of smoking cessation and to decrease relapse. Varenicline was approved for use in the United States in 2006 and is widely used in smoking cessation programs. Varenicline is available in tablets of 0.5 and 1 mg under the brand name Chantix. The usually recommended regimen is to start with 0.5 mg once daily and increase to a maintenance dose of 1 mg twice daily, continuing therapy for at least 12 weeks after smoking cessation. Common side effects include nausea, vivid dreams, insomnia, anxiety, depression, dizziness, drowsiness, headache, dry mouth, and change in appetite, some of the symptoms being those of nicotine withdrawal. Varenicline has been reported to cause hypersensitivity reactions including Stevens Johnson syndrome.

### Hepatotoxicity

Varenicline has not been associated with rates of serum enzyme elevations during therapy greater than occurs with placebo therapy, but information on these abnormalities is limited and occasional instances of asymptomatic ALT elevations leading to drug discontinuation have been reported. In prelicensure pivotal registration trials in several thousand patients, varenicline was not associated with cases of jaundice or hepatitis. Since licensure, rare case reports of serum enzyme elevations without jaundice arising within 4 weeks of starting varenicline have been published, but largely in patients with other causes of liver injury (alcoholic liver disease, hepatitis C). The injury was self-limited in course and not associated with immunoallergic or autoimmune features. In Iceland, a single case of varenicline hepatotoxicity has been reported (Case 1), there having been an estimated 20,000 persons treated with the drug in the country since its introduction.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which varenicline might cause liver injury is not known. Varenicline undergoes minimal hepatic metabolism and is excreted largely unchanged in the urine.

### Outcome and Management

The rare reports of hepatotoxicity attributed to varenicline therapy have been mild and self-limiting. Varenicline has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome.

Agents in clinical use to aid in smoking cessation and to treat nicotine withdrawal symptoms include bupropion, nicotine, and varenicline.

Drug Class: Substance Abuse Treatment Agents

## CASE REPORT

### Case 1. Mild acute hepatitis arising 3 weeks after starting varenicline.(1)

A 50 year old woman developed nausea and fatigue 3 weeks after starting varenicline for smoking cessation. She stopped the medication promptly but during the next week developed itching, dark urine, and jaundice. She had no history of liver disease, alcohol abuse, risk factors for viral hepatitis or drug allergies. Her other medical conditions included hypertension and cerebral aneurysm for which she was taking atenolol, amlodipine and a thiazide diuretic. On examination, she was jaundiced but had no signs of chronic liver disease. Blood tests showed a total serum bilirubin of 5.6 mg/dL, ALT 466 U/L, AST 207 U/L, alkaline phosphatase 249 U/L and GGT 976 U/L. There was no fever, rash or peripheral eosinophilia. Tests for hepatitis A, B, C, E and Epstein Barr virus and cytomegalovirus were negative as well serum autoantibodies. An abdominal CT scan showed no liver or biliary abnormalities. She was not admitted to the hospital, did not undergo liver biopsy and received no specific therapy. Her routine medications were continued. Over the next few weeks she improved (Table) and liver tests were normal or near normal when she was seen 6 weeks after onset.

#### Key Points

Medication: | Varenicline (3 weeks), initially 0.5 mg increasing to 2 mg daily
Pattern: | Mixed (R=4.3)
Severity: | 2+ moderate (jaundice, not hospitalized)
Latency: | 3 weeks to onset of symptoms
Recovery: | 5-6 weeks
Other medications: | Atenolol, amlodipine, bendroflumethiazide with potassium

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | Varenicline started
1 month | 7 days | 466 | 249 | 5.6 | Jaundiced
| 12 days | 429 | 214 | 3.0 | CT scan
| 15 days | 421 | 107 | 1.5
2 months | 6 weeks | 53 | 53 | 0.8 | Asymptomatic
Normal Values | | <45 | <105 | <1.2

#### Comment

The patient developed a mild, self-limited acute hepatitis 3 weeks after starting varenicline. Other diagnoses were carefully ruled out. Very few cases of varenicline hepatotoxicity have been described, and most were not completely convincing because of the presence of other liver diseases. This case with a latency of 3 weeks and a self-limited mild course of a mixed hepatitis is reasonably convincing. Varenicline has little hepatic metabolism and it is given in low doses (2 mg daily), and thus does not have features usually associated with hepatotoxicity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Varenicline – Chantix®

DRUG CLASS

Substance Abuse Treatment Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Varenicline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Varenicline | 249296-44-4 | C13-H13-N3

## CITED REFERENCE

1 Mogensen H, Björnsson ES. (2015). Varenicline-induced acute liver injury with jaundice. Hepatology.

## ANNOTATED BIBLIOGRAPHY

References updated: 22 July 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of varenicline).
O'Brien CP. Nicotine. Drug us disorders and addiction. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 437-9. (Textbook of pharmacology and therapeutics mentions that varenicline partially stimulates nicotinic receptors, thereby reducing craving and preventing most withdrawal symptoms).
Gonzales D, Rennard SI, Nides M, Oncken C, Azoulay S, Billing CB, Watsky EJ, et al. (2006). the Varenicline Phase 3 study Group. Varenicline, an alpha4beta2 nicotinic acetylcholine receptor partial agonist, vs sustained-release bupropion and placebo for smoking cessation: a randomized controlled trial. JAMA. (Controlled trial of varenicline vs bupropion vs placebo for 12 weeks in 1025 smokers; no instances of hepatitis or clinically apparent liver injury were reported, but results of blood chemistry testing not discussed).
Jorenby DE, Hays JT, Rigotti NA, Azoulay S, Watsky EJ, Williams KE, Billing CB, et al. (2006). Varenicline Phase 3 study Group. Efficacy of varenicline, an alpha4beta2 nicotinic acetylcholine receptor partial agonist, vs placebo or sustained-release bupropion for smoking cessation: a randomized controlled trial. JAMA. (Controlled trial of varenicline vs bupropion vs placebo for 12 weeks in 1027 smokers; no instances of hepatitis or jaundice were reported; results of serial blood chemistry determinations not given).
Tonstad S, Tonnesen P, Hajek P, Williams KE, Billing CB, Reeves KR. (2006). Varenicline Phase 3 Study Group. Effect of maintenance therapy with varenicline on smoking cessation: a randomized controlled trial. JAMA. (Controlled trial of varenicline vs placebo continuation for 12 weeks after achieving abstinence with initial 12 weeks of therapy; no hepatic serious adverse events occurred, no discussion of ALT elevations).
Nides M, Oncken C, Gonzales D, Rennard S, Watsky EJ, Anziano R, Reeves KR. (2006). Smoking cessation with varenicline, a selective alpha4beta2 nicotinic receptor partial agonist. Arch Intern Med. (Controlled trial of several doses of varenicline vs bupropion or placebo for 12 weeks in 626 smokers; "The frequency of clinically significant laboratory test abnormalities was low and similar across all treatment groups").
Oncken C, Gonzales D, Nides M, Rennard S, Watsky E, Billing CB, Anziano R, et al., Varenicline Study Group. (2006). Efficacy and safety of the novel selective nicotinic acetylcholine receptor partial agonist, varenicline, for smoking cessation. Arch Intern Med. (Controlled trial of 3 regimens of varenicline vs placebo for 12 weeks in 647 smokers; "results of clinical laboratory tests...demonstrated no clinically meaningful differences between varenicline and placebo").
Williams KE, Reeves KR, Billing CB, Pennington AM, Gong J. (2007). A double-blind study evaluating the long-term safety of varenicline for smoking cessation. Curr Med Res Opin. (Among 377 patients enrolled in a placebo controlled trial of varenicline for smoking cessation, the most common side effects were nausea, gastrointestinal symptoms, weight gain, insomnia and abnormal dreams; 2 patients stopped therapy because of ALT or AST elevations, but values and follow up not provided).
Hays JT, Ebbert JO, Sood A. (2008). Efficacy and safety of varenicline for smoking cessation. Am J Med. (Review of mechanism of action, clinical efficacy and safety of varenicline; in placebo controlled trials "the frequency of clinically significant laboratory test abnormalities was low and similar across the treatment groups").
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to varenicline).
Franck AJ, Sliter LR. (2009). Acute hepatic injury associated with varenicline in a patient with underlying liver disease. Ann Pharmacother. (53 year old man with end-stage alcoholic liver disease [initial ALT ~30 U/L, Alk P ~130 U/L] awaiting liver transplantation developed nausea and pruritus 1 week after starting a course of varenicline [bilirubin 1.0 mg/dL, ALT 657 U/L, Alk P 183 U/L], resolving within 1-2 months of stopping).
Silva RR. (2009). Two recent updates for psychiatric conditions. J Child Adolesc Psychopharmacol. (Brief editorial review of the postmarketing product update on varenicline and bupropion warning of suicidal ideation and behaviors with their use).
Jiménez-Ruiz C, Berlin I, Hering T. (2009). Varenicline: a novel pharmacotherapy for smoking cessation. Drugs. (Review of the structure, pharmacology, metabolism, clinical efficacy and safety of varenicline; no discussion of hepatotoxicity).
(2009). Safety of smoking cessation drugs. Med Lett Drugs Ther. (Concise review of safety of medications used for smoking cessation; varenicline is mentioned as the most effective drug available, common side effects are nausea, sleep disturbances, vivid dreams, headache, constipation, vomiting, flatulence and dry mouth; no mention of hepatic effects).
McNeil JJ, Piccenna L, Ioannides-Demos LL. (2010). Smoking cessation-recent advances. Cardiovasc Drugs Ther. (Review of mechanisms of action, efficacy and safety of smoking cessation therapies; hepatotoxicity is not discussed).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to varenicline or other agents used to treated substance abuse).
Cui Q, Robinson L, Elston D, Smaill F, Cohen J, Quan C, McFarland N, et al. (2012). Safety and tolerability of varenicline tartrate (Champix(®)/Chantix(®)) for smoking cessation in HIV-infected subjects: A pilot open-label study. AIDS Patient Care STDS. (Among 36 HIV-positive smokers treated with varenicline for 24 weeks, mild ALT elevations occurred in 19%, but none were above 2.5 times ULN or associated with symptoms or jaundice).
Sprague D, Bambha K. (2012). Drug-induced liver injury due to varenicline: a case report. BMC Gastroenterol. (69 year old man developed nausea followed by jaundice within 1 week of starting varenicline and stopped it promptly, presenting several weeks later [bilirubin 12 mg/dL, ALT 1592 U/L, Alk P 254 U/L], resolving within two months; patient was also positive for anti-HCV and HCV RNA and liver biopsy during follow up showed chronic hepatitis).
Litten RZ, Ryan ML, Fertig JB, Falk DE, Johnson B, Dunn KE, Green AI, et al. (2013). NCIG (National Institute on Alcohol Abuse and Alcoholism Clinical Investigations Group) Study Group. A double-blind, placebo-controlled trial assessing the efficacy of varenicline tartrate for alcohol dependence. J Addict Med. (Among 200 adults with alcohol dependence treated with varenicline or placebo for 13 weeks, percent of heavy drinking days decreased more on varenicline, but abstinence rates were similar, and adverse events included nausea [37% vs 18%], abnormal dreams [28% vs 12%], constipation [9% vs 2%], and abnormalities of “liver function tests” [0% vs 1%]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to varenicline).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attribute to varenicline).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to varenicline).
Mogensen H, Björnsson ES. (2015). Varenicline-induced acute liver injury with jaundice. Hepatology. (50 year old Icelandic woman developed fatigue 3 weeks after starting varenicline, which she promptly stopped but went on to develop jaundice and itching [bilirubin 5.6 mg/dL, ALT 466 U/L, Alk P 249 U/L], with rapid recovery: Case 1).
Sakakibara M, Ohkawa K, Nawa T, Abe Y, Kusakabe A, Imai T, Katayama K. (2018). Two-step progression of varenicline-induced autoimmune hepatitis. Clin J Gastroenterol. (46 year old Asian woman developed elevations in serum enzymes while on varenicline, which improved upon stopping but rose again 8 weeks later with appearance of ANA positivity, ultimately requiring corticosteroid therapy).
(2019). Drugs for smoking cessation. Med Lett Drugs Ther. (Concise review of the mechanisms of action, clinical efficacy, safety and costs of drugs for smoking cessation mentions that side effects of varenicline include nausea and constipation, dizziness and headache and sleep disturbances with insomnia and vivid dreams; no mention of ALT elevations or hepatotoxicity).
Desai RJ, Good MM, San-Juan-Rodriguez A, Henriksen A, Cunningham F, Hernandez I, Good CB. (2019). Varenicline and nicotine replacement use associated with US Food and Drug Administration drug safety communications. JAMA Netw Open. (Varenicline has been labelled with warnings concerning serious neuropsychiatric and cardiovascular adverse events, but in postmarketing studies these complications have not been found more frequent with varenicline than placebo or no treatment, and analyses of Veterans Administration and Medicare/Medicaid prescribing has documented declines in the use of the drug after the FDA warnings which may have had the effect of an increase in smoking related morbidity and mortality).
Carson-Chahhoud KV, Smith BJ, Peters MJ, Brinn MP, Ameer F, Singh K, Fitridge R, et al. (2020). Two-year efficacy of varenicline tartrate and counselling for inpatient smoking cessation (STOP study): A randomized controlled clinical trial. PLoS One. (Among 1959 Australian adults admitted with smoking related illnesses to 3 hospitals between 2008 and 2011 who were treated with counseling with or without varenicline, smoking cessation was more frequent with varenicline which was well tolerated, common adverse events being nausea [16% vs 1.5%], abnormal dreams [6% vs 1%], headache [6% vs 1.5%], insomnia [5% vs 2%] and dizziness [2% vs 0.5%]; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Varenicline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Varenicline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Varenicline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Varenicline)